# Golodirsen

## OVERVIEW

### Introduction

Golodirsen is a synthetic RNA antisense oligonucleotide designed to cause skipping of abnormal exons in the synthesis of the dystrophin gene and that is used to treat Duchenne muscular dystrophy. Golodirsen has not been reported to cause ALT elevations during therapy and has not been linked to instances of acute liver injury with symptoms and jaundice.

### Background

Golodirsen (go” loh dir’ san) is a synthetic antisense oligonucleotide designed to cause exon 53 skipping during the processing of the mRNA of the dystrophin gene, which encodes an essential protein for muscle integrity. Patients with Duchenne muscular dystrophy typically have deletion mutations in exons [43 to 55], which disrupt the open-reading frame and the normal synthesis of dystrophin. The lack of functional dystrophin leads to damage to muscles during contraction that eventually results in replacement of normal muscle by fibrous tissue and fat. Duchenne muscle dystrophy is an X-linked disorder that presents clinically in boys by the age of 2 or 3 years and often results in loss of ambulation by age 10, ventilation dependency by age 20, and premature death within 5 to 20 years thereafter. In animal models of muscular dystrophy, golodirsen resulted in skipping of exon 53 and creation of a truncated but functional dystrophin gene. In small placebo controlled trials of golodirsen in patients with Duchenne muscular dystrophy with mutations in exon 53 amenable to correction by the drug, dystrophin protein levels increased in treated subjects and not in controls. The studies did not demonstrate convincing evidence of clinical improvement. Nevertheless, based upon changes in dystrophin levels, golodirsen was granted accelerated approval for use in the United States in 2019. Its indications are limited to patients with Duchenne muscular dystrophy with a confirmed mutation that was correctable by exon 53 skipping. Golodirsen is available in solution in single dose vials of 100 mg in 2 mL. The recommended regimen is 30 mg per kg body weight once weekly by intravenous infusion. Side effects of golodirsen include headache, fever, falls, abdominal pain, cough, and nausea. Injection site reactions and hypersensitivity reactions including rash, pruritus, urticaria and skin exfoliation have occurred. Renal toxicity, which was observed in preclinical studies in animals was not found in human trials. The weekly intravenous infusions of golodirsen sometimes require an indwelling venous access catheter, which may predispose to complications of infection and septicemia with long term use.

### Hepatotoxicity

Duchenne muscular dystrophy is rare affecting ~1:5000 newborn boys, and those with deletion mutants in exon 53 that would be amenable to golodirsen therapy account for only 8% of patients with the disease. The pivotal trials of golodirsen were conducted in rather small numbers of patients, and the full spectrum of hepatotoxicity may not be fully known. Nevertheless, serum aminotransferase elevations were not described in the registration trials of golodirsen and there were no discontinuations for liver adverse events and no episodes of clinically apparent liver injury. Thus, golodirsen has not been linked to instances of acute hepatitis or jaundice, but it has had limited clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reasons why golodirsen or other RNA antisense therapeutics used for Duchenne muscular dystrophy might cause hepatic injury are unknown. One possibility is that exon skipping may cause disruption of translation of other genes in hepatocytes. Golodirsen and other antisense molecules are largely excreted unchanged in the urine and have little effect on cytochrome P450 enzyme activities or metabolism of other drugs.

### Outcome and Management

Golodirsen therapy has not been associated with liver injury, either in the form of minor serum enzyme elevations or clinically apparent liver injury. There is no reason to suspect cross reactivity of the hepatic injury with other antisense therapies or drugs used to treat Duchenne muscular dystrophy. Routine monitoring of liver tests during therapy is not generally recommended.

Drug Class: Genetic Disorder Agents

Other Therapeutic Antisense RNA Agents for Duchenne Muscular Dystrophy: Casimersen, Eteplirsen, Viltolarsen

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Golodirsen – Vyondys 53®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=35c227d1-5b24-44b0-b5d3-f0f6b1c46bd5)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Golodirsen | 1422959-91-8 | C305-H481-N138-O112-P25

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2022

Abbreviations: siRNA, small interfering RNA; RNAi, RNA interference.

Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to siRNA or antisense therapies or medications for muscular dystrophy).
Chi X, Gatti P, Papoian T. (2017). Safety of antisense oligonucleotide and siRNA-based therapeutics. Drug Discov Today. (Oligonucleotide and siRNA based treatments are currently being evaluated in several diseases and have been found to have unexpected toxicities including antisense thrombocytopenia [mipomersen, drisapersen] and peripheral neuropathy [revusiran]; no discussion of hepatotoxicity).
Levin AA. (2019). Treating disease at the RNA level with oligonucleotides. N Engl J Med. (Review of the mechanism of action, current status and future promise of RNA based therapies that use synthetic oligonucleotides to modulate RNA function and have been applied to diseases ranging from hemophilia, amyloidosis, muscular dystrophy and hyperlipidemia).
Messina S, Vita GL. (2018). Clinical management of Duchenne muscular dystrophy: the state of the art. Neurol Sci. (Review of current optimal clinical management of Duchenne muscular dystrophy focusing upon standard respiratory, cardiovascular, orthopedic and nutritional support as well as recent innovative approaches to therapy including exon and premature stop codon suppression).
Setten RL, Rossi JJ, Han SP. (2019). The current state and future directions of RNAi-based therapeutics. Nat Rev Drug Discov. (Extensive review of gene silencing using RNA interference pathways and the potential of RNAi therapeutics which have promise in many genetic and acquired diseases including transthyretin amyloidosis [transthyretin], HIV infection [CCR5], HBV [HBV mRNA], alpha-1-antitrypsin deficiency [zz A1AT], hypercholesterolemia [PCSK9]).
Verhaart IEC, Aartsma-Rus A. (2019). Therapeutic developments for Duchenne muscular dystrophy. Nat Rev Neurol. (Review of mechanisms of action, challenges, and clinical efficacy of new molecular approaches to therapy of muscular dystrophy including gene therapy with viral vectors, exon skipping using antisense oligonucleotides [casimersen, eteplirsen, drisapersen, golodirsen], stop coding readthrough [ataluren], gene addition, CRISPR-Cas9 genome editing, and myoblast transplantation).
FDA Multi-Disciplinary Review and Evaluation. Golodirsen. 2019. Available at: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211970Orig1s000MedR.pdf (The FDA clinical review of golodirsen for efficacy and safety found minor increases in dystrophin levels in muscle biopsies but no improvement in clinical measures such as 6 minute walk test distances; therapy required intravenous infusions once weekly and insertion of a venous access port, but there were no serious adverse events attributable to the medication and no hepatic related serious adverse events or discontinuations because of liver toxicity; no mention of changes in ALT levels during therapy).
Heo Y-A. (2020). Golodirsen: first approval. Drugs. (Review of the mechanism of action, history of development, clinical efficacy and safety of golodirsen shortly after its approval for use in Duchenne muscular dystrophy mentions that in the registration trial, all patients showed exon 53 skipping responses and the mean dystrophin levels from muscle biopsies increased from baseline, but that clinical improvement rates were not reported, while adverse events in treated vs control subjects included headache [41% vs 10%], fever [41% vs 14%], falls [29% vs 19%], abdominal pain [27% vs 10%], cough [27% vs 19%], and nausea [20% vs 10%], but does not mention ALT elevations or hepatotoxicity).
Aartsma-Rus A, Corey DR. (2020). The 10th oligonucleotide therapy approved: golodirsen for Duchenne muscular dystrophy. Nucleic Acid Ther. (Review of the efficacy and safety of 10 oligonucleotide therapies approved in the US or Europe, including specific discussions of fomivirsen, mipomersen, eteplirsen, nusinersen, patisiran, givosiran and golodirsen).
Frank DE, Schnell FJ, Akana C, El-Husayni SH, Desjardins CA, Morgan J, Charleston JS, et al., SKIP-NMD Study Group. (2020). Increased dystrophin production with golodirsen in patients with Duchenne muscular dystrophy. Neurology. (Among 25 boys with Duchenne muscular dystrophy treated with golodirsen for 48 weeks, dystrophin levels increased from approximately 0.10% of normal to 1.02%, and all had evidence of increased exon skipping).
(2020). Golodirsen (Vyondys 53) for Duchenne muscular dystrophy. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy and safety of golodirsen shortly after its approval for use in Duchenne muscular dystrophy in the US; adverse effects included headache, fever, abdominal pain, cough, nasopharyngitis, nausea, rash and urticaria; no mention of ALT elevations or hepatotoxicity).
Alhamadani F, Zhang K, Parikh R, Wu H, Rasmussen TP, Bahal R, Zhong XB, Manautou JE. (2022). Adverse drug reactions and toxicity of the Food and Drug Administration-approved antisense oligonucleotide drugs. Drug Metab Dispos. (Review of the adverse side effects of oligonucleotide therapies approved in the US or Europe, including specific discussions of fomivirsen, mipomersen, nusinersen, inotersen, eteplirsen, golodirsen, viltolarsen and casimersen; hepatotoxicity has been described with use of mipomersen [now withdrawn] and inotersen, but not with the agents used for Duchenne muscular dystrophy).
Servais L, Mercuri E, Straub V, Guglieri M, Seferian AM, Scoto M, Leone D, et al., SKIP-NMD Study Group. (2022). Long-term safety and efficacy data of golodirsen in ambulatory patients with Duchenne muscular dystrophy amenable to exon 53 skipping: a first-in-human, multicenter, two-part, open-label, phase 1/2 trial. Nucleic Acid Ther. (Among 25 boys with Duchenne muscular dystrophy enrolled in a phase 1 randomized placebo controlled trial followed by an open label study of golodirsen [30 mg/kg intravenously once weekly] for 168 weeks, dystrophin levels increased over the first 48 weeks but there was a steady decline in 6 minute walk time distance and forced vital capacity on yearly determinations, although the amount of change was less than in a matched historical control group).

## OTHER REFERENCE LINKS

1 Recent References on Golodirsen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Golodirsen/AE)%20AND%20Human%5bMH%5d%20AND%20(drug%20induced%20liver%20injury%20OR%20jaundice/CI%20OR%20bile%20duct%20diseases/CI%20OR%20liver/DE%20OR%20liver%20diseases/CI)%20AND%20(%221900%5C%5C1%5C%5C1%22%5bEDat%5d:%222999%5C%5C12%5C%5C31%22%5bEDat%5d))
2 Trials on Golodirsen: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=Golodirsen)